# Verapamil

## OVERVIEW

### Introduction

Verapamil is a first generation calcium channel blocker used for treatment of hypertension, angina pectoris and superventricular tachyarrhythmias. Verapamil has been linked to a low rate of serum enzyme elevations during therapy and to rare instances of clinically apparent acute liver injury.

### Background

Verapamil (ver ap' a mil) belongs to the phenylalkylamine class of calcium channel blockers and is used to treat hypertension and angina pectoris as well as atrial tachyarrhythmias. Like other calcium channel blockers, verapamil acts by blocking the influx of calcium ions into vascular smooth muscle and cardiac muscle cells during membrane depolarization. This action causes relaxation of vascular and arterial smooth muscle cells, resulting in arterial vasodilation and a decrease in cardiac work and oxygen consumption. Verapamil also decreases the rate of the sinus node pacemaker and slows atrial-ventricular conduction, making it effective in controlling some superventricular tachyarrhythmias (an action not shared by all calcium channel blockers). Verapamil was the first calcium channel blocker approved in the United States (1981) and it remains in wide use with more than eight million prescriptions filled yearly. Several generic formulations are available in tablet sizes of 40, 80 or 120 mg; specific commercial names include Calan, Isoptin, Apo-, Novo-, or Nu-Verap, and Verelan. For hypertension and angina pectoris, the recommended dose in adults is 120 to 480 mg daily in three divided doses. Chronic therapy is typical. Extended release formulations are available for once-daily dosing and intravenous formulations for treatment of atrial fibrillation or flutter. Like other calcium channel blockers, verapamil is generally well tolerated and side effects are largely due to its vasodilating activities and can include headache, flushing, dizziness, fatigue, nausea, diarrhea, palpitations, peripheral edema and skin rash.

### Hepatotoxicity

Chronic therapy with verapamil is associated with a low rate of serum aminotransferase elevations that are usually mild and may resolve even with continuation of therapy. Clinically apparent liver injury with jaundice or symptoms from verapamil is uncommon and usually presents with fatigue, weakness with or without jaundice 2 to 8 weeks after starting the drug. The pattern of injury is usually mixed or cholestatic. Acute presentation can include fever, rash, arthralgias and eosinophilia, but these immunoallergic features are rarely prominent. Rapid recurrence with rechallenge has been reported. Autoantibodies are usually not present. Most cases have been mild and self-limited. Recovery is prompt with stopping verapamil and no cases of chronic hepatitis or vanishing bile duct syndrome have been attributed to its use. At least a dozen instances of acute liver injury attributed to verapamil have been published and the nature of the reaction is probably an idiosyncratic and immunologic.

Likelihood score: B (Likely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of clinically apparent hepatotoxicity from verapamil is probably hypersensitivity. Verapamil is a derivative of papaverine which also causes an allergic form of hepatitis. Verapamil is metabolized by multiple cytochrome P450 enzymes including CYP 3A4 and is susceptible to drug-drug interactions with agents that are subtrates of CYP 3A4 as well as with inducers and inhibitors of the enzyme.

### Outcome and Management

The severity of liver injury from verapamil ranges from mild and transient serum enzyme elevations to mild-to-moderate, but self-limited jaundice. Complete recovery is expected after stopping the drug and recovery is usually rapid (2 to 6 weeks) depending upon the severity. Rechallenge leads to recurrence and should be avoided. There is little information on cross sensivity of liver injury with other calcium channel blockers.

Drug Class: Cardiovascular Agents, Calcium Channel Blockers

Other Drugs in the Subclass, Calcium Channel Blockers: Amlodipine, Diltiazem, Felodipine, Isradipine, Nicardipine, Nifedipine, Nimodipine, Nisoldipine

## CASE REPORT

### Case 1. Asymptomatic elevations in serum enzymes during verapamil therapy.

[Modified from a case in the database of the Drug Induced Liver Injury Network.]

A 54 year old woman with migraine headaches was started on verapamil in a dose of 80 mg daily, which was increased to 120 mg daily 3 weeks later. On routine testing 6 months later, she was found to have marked elevations in serum alkaline phosphatase and moderate increases in serum ALT and AST without jaundice (Table). Previous liver test results had been normal. She denied all symptoms and had no history of exposure to hepatitis, toxins or alcohol. She had a complex medical history and was also taking estrogens for menopausal symptoms, rabeprazole for acid reflux, valacyclovir for recurrent genital herpes, zolpidem for insomnia, fexofenadine for allergic rhinnitis, aspirin for coronary prophylaxis, and acetaminophen intermittently at low dosage for miscellaneous muscular-skeletal complaints. Tests for acute hepatitis A, B and C as well as autoimmune markers were negative. An abdominal ultrasound showed a heterogenous texture to the liver, but no gallstones or evidence of bile duct abnormalities. Verapamil was discontinued and laboratory test results returned to normal except for minimal elevations in alkaline phosphatase. Her other medications were continued.

#### Key Points

Medication: | Verapamil, 80-120 mg daily
Pattern: | Cholestatic (R=0.6)
Severity: | 1+ (never jaundiced, never hospitalized)
Latency: | Five to six months
Recovery: | Near complete within 2 months
Other medications: | Rabeprazole, valacyclovir, zolpidem, fexofenadine, aspirin, intermittent acetaminophen

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
| | Verapamil started at a dose of 80 mg/day
3 weeks | | 41 | 86 | 0.4 | Dose 120 mg/day
24 weeks | | 25 | 165 | 0.4
25 weeks | | 325 | 2171 | 1.1
26 weeks | | 251 | 1118 | 0.7 | Normal Ultrasound
| 0 | Verapamil stopped after 26 weeks
27 weeks | 1 week | 97 | 696 | 0.5 | AMA negative
28 weeks | 2 weeks | 70 | 449 | 0.4
30 weeks | 3 weeks | 29 | 266 | 0.3
33 weeks | 6 weeks | 25 | 165 | 0.4
36 weeks | 8 weeks | 37 | 161 | 0.2
Normal Values | | <60 | <115 | <1.2

#### Comment

This patient was asymptomatic of liver disease, but was found to have serum enzyme abnormalities on routine blood testing after she had been on verapamil for six months. Serum alkaline phosphatase was markedly elevated (~10-20 fold) while serum aminotransferase levels were only moderately increased (~4-6 fold). Serum bilirubin levels had increased, although not into the abnormal range. There were no features that suggested hypersensitivity (rash, fever or eosinophilia). Evaluation for other causes of liver disease was unrevealing, and stopping verapamil was followed by a rapid improvement. The latency of 5 to 6 months was unusual for verapamil, most published cases arising within 2 to 8 weeks of starting. However, the cholestatic pattern of serum enzymes, absence of other obvious causes of liver disease and the improvement with drug withdrawal were compatible with verapamil induced hepatotoxicity.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Verapamil – Generic, Calan®

DRUG CLASS

Cardiovascular Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=verapamil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Verapamil | 52-53-9 | C27-H38-N2-O4 | Verapamil chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 11 January 2017

Zimmerman HJ. Calcium channel blockers. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 646-7. (Expert review of hepatotoxicity published in 1999; among calcium channel blockers, diltiazem, nifedipine, bepridil and verapamil have been incriminated in instances of hepatic injury).
De Marzio DH, Navarro VJ. Calcium channel blockers. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 524. (Review of hepatotoxicity of calcium channel blockers mentions that diliazem and verapamil have been implicated in causing cholestatic liver injury in a small number of patients).
Michel T, Hoffman BB. Calcium channel antagonists. Treatment of myocardial ischemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 755-60. (Textbook of pharmacology and therapeutics).
Sandler G, Clayton GA, Thornicroft SG. Clinical evaluation of verapamil in angina pectoris. Br Med J 1968; 3: 224-7. (Small controlled trial of verapamil in 16 patients with angina; "side effects were minimal" and no liver related adverse events were reported). 4969551
Brodsky SJ, Cutler SS, Weiner DA, Klein MD. Hepatotoxicity due to treatment with verapamil. Ann Intern Med 1981; 94:490-1. (55 year old man developed serum enzyme elevations without symptoms or jaundice 5 weeks after starting verapamil [bilirubin 1.2 mg/dL, ALT 800 U/L, Alk P 220 U/L] and had a similar response upon rechallenge [bilirubin 1.5 mg/dL, ALT 1500 mg/dL, Alk P 310 U/L], both episodes resolving within weeks of stopping).7212507
Stern EH, Pitchon R, King BD, Wiener I. Possible hepatitis from verapamil. N Engl J Med 1982; 306: 612-3. (48 year old man treated with verapamil for 14 days developed abdominal pain [bilirubin 1.7 mg/dL, ALT 61 U/L, Alk P normal], which rapidly resolved upon stopping). 7057821
Nash DT, Feer TD. Hepatic injury possibly induced by verapamil. JAMA 1983; 249:395-6. (61 year old woman developed serum enzymes elevations with symptoms, but no jaundice 2 weeks after starting verapamil [bilirubin 1.6 mg/dL, ALT 835 U/L, Alk P 399 U/L], resolving rapidly with stopping). 6848831
Guarascio P, D’Amato C, Sette P, Conte A, Visco G. Liver damage from verapamil. Br Med J 1984; 288: 362-3. (47 year old man developed fever, right upper quadrant pain and jaundice 2 weeks after starting verapamil [bilirubin 7.5 mg/dL, ALT 145 U/L, Alk P 170 U/L, 17% eosinophils], resolving within 4 weeks of stopping). 6419928
Hare DL, Horowitz JD. Verapamil hepatotoxicity: a hypersensitivity reaction. Am Heart J 1986; 111:160-1. (71 year old woman developed abdominal pain 6 weeks after starting verapamil [bilirubin 1.6 mg/dL, AST 170 U/L, Alk P 1731 U/L, 2% eosinophils], resolving in 4 weeks and recurring after challenge with a single dose [AST 210 U/L]). 3953378
Burgunder JM, Abernethy DR, Lauterburg BH. Liver injury due to verapamil. Hepatogastroenterology 1988; 35: 169-70. (56 year old woman developed rash, pruritus and jaundice 2 months after starting verapamil [bilirubin 4.1 mg/dL, ALT 5 times ULN, Alk P 2.3 times ULN], recurring within 14 days of restarting verapamil). 3181862
Veluvolu P, Whalen JP, Collier DC, Friedman B. Scintigraphic demonstration of hepatocellular damage after verapamil toxicity. Clin Nucl Med 1988; 13: 368. (60 year old man developed elevations in ALT [1030 U/L] and LDH [1085 U/L] one day after a single dose of verapamil; no attempts made to exclude other causes). 3390984
de Arriba G, Garcia-Martin F, Sanchez-Heras M, Aldeguer M, Tejero E, Jarillo MD. Hepatotoxicity due to verapamil hydrochloride. Eur J Med 1993; 2: 179-81. (55 year old man developed cholestatic pattern of enzyme elevations without jaundice 6 weeks after starting verapamil [bilirubin 1.2 mg/dL, ALT 534 U/L, Alk P 2715 U/L, 1% eosinophils], resolving within 8 weeks of stopping). 8261063
Kumar KL, Colley CA. Verapamil-induced hepatotoxicity. West J Med 1994; 160: 485-6. (50 year old man developed cholestatic pattern of enzyme elevations without jaundice 8 weeks after starting verapamil therapy [bilirubin 1.9 mg/dL, AST 209 U/L, Alk P 533 U/L], resolving within 4 to 6 weeks of stopping). 8048248
Odeh M, Oliven A. Verapamil-associated liver injury. Harefuah 1998; 134: 36-7 [Hebrew]. (54 year old woman developed elevations in Alk P [298 U/L] and ALT [72 U/L] with mild symptoms, but no jaundice 6 weeks after starting verapamil that resolved within 5 weeks of stopping). 9517278
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, but none were attributed to a calcium channel blocker). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Summary of 25 years of adverse drug reaction reporting in Sweden identified 103 cases of drug induced acute liver failure; only one case was possibly linked to a calcium channel blocker: felodipine). 16165719
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, calcium channel blockers were implicated as a sole agent in 2 cases [1 amlodipine, 1 verapamil: case 1] and as one of several agents in 2 cases [both amlodipine]). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but no case was attributed to verapamil or other calcium channel blockers). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 114: 1419-25. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/23419359) (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but calcium channel blockers were not implicated in any case).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases; one case was attributed to verapamil, but none to other calcium channel blockers). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 39 [4%] were due to antihypertensive agents including 4 due to calcium channel blockers [amlodipine in 1 and verapamil in 3 instances]). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Verapamil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=verapamil/AE+AND+Human%5BMH%5D+AND+(%20drug-induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221998/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Verapamil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=verapamil)